# Promethazine

## OVERVIEW

### Introduction

Promethazine is first generation antihistamine that belongs to the phenothiazine class and is used predominantly as an antiemetic to treat nausea and vomiting and prevent motion sickness. Despite its phenothiazine structure, promethazine has not been linked to instances of clinically apparent acute liver injury.

### Background

Promethazine (proe meth' a zeen) is a first generation antihistamine that is used widely to treat and prevent nausea and to a lesser extent to treat allergy symptoms and as a mild sedative. Promethazine belongs to the phenothiazine class of antihistamines and is a potent antiemetic. Because of its sedating effects, promethazine is also used for anxiety, tension and as a mild sleeping aid. Promethazine was approved for use in the United States in 1957 and continues to be widely used with more than 10 million prescriptions filled yearly. Promethazine is available in multiple forms including tablets, capsules, syrups, suppositories and liquid solution for injection generically and under the brand name Phenergan. Unlike other antihistamines, promethazine is not available over-the-counter. Current indications include nausea, preoperative sedation, nighttime sedation, rhinitis and allergic symptoms, cough and respiratory symptoms, and treatment and prevention of motion sickness. The typical recommended dose in adults is 12.5 to 25 mg orally or by rectal suppository, which can be repeated every 4 to 6 hours as necessary. Common side effects include excessive sedation, impairment of motor function, confusion, dizziness, extrapyramidal symptoms, blurred vision, dry mouth and throat, palpitations, tachycardia, abdominal distress, constipation and headache. Antihistamines can worsen urinary retention and glaucoma.

### Hepatotoxicity

Despite widespread use and similarity to phenothiazines, promethazine has not been clearly linked to liver test abnormalities or to clinically apparent liver injury. The reason for its safety may relate to low daily dose and limited duration of use.

Likelihood score: E (unlikely to be a cause of clinically apparent liver injury).

References on the safety and potential hepatotoxicity of antihistamines are given together after the Overview section on Antihistamines.

Drug Class: Antihistamines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Promethazine – Generic, Phenergan®

DRUG CLASS

Antihistamines

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Promethazine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Promethazine | 60-87-7 | C17-H20-N2-S | Promethazine Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Promethazine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Promethazine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Promethazine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Promethazine)